# Cascara

## OVERVIEW

### Introduction

Cascara is a popular herbal medication and over-the-counter therapy of constipation. Cascara is generally safe and well tolerated, but can cause adverse events including clinically apparent liver injury when used in high doses for longer than recommended periods.

### Background

Cascara sagrada is an herbal medication used for centuries as a laxative which is now available in the United States without prescription for short term treatment of constipation. Cascara is typically an extract from the dried, aged bark of Rhamnus purshiana, a species of buckthorn tree or shrub native to North America. Cascara sagrada is Spanish for “sacred bark” and was used for centuries by Native Americans as a laxative. Cascara became accepted in western medical practice in the 19th century and is still used in over-the-counter laxative preparations, often in combination with other herbals such as aloe vera. The active laxative components in cascara are anthraquinone derivatives and their glucosides, referred to as cascarosides. They appear to act locally as an irritant to the colon promoting peristalsis and stool evacuation. Anthraquinones also inhibit reabsorption of electrolytes and water from the colon. Cascara is minimally absorbed. The typical dose is 300 mg once daily, but it is recommended for short term use only (less than one week). Side effects include abdominal cramps and electrolyte imbalance. Long term use or abuse can lead to “cathartic” colon with diarrhea, cramps, weight loss and darkened pigmentation of the colonic mucosa.

### Hepatotoxicity

Use of cascara in the recommended doses for a limited period of time has been associated with few side effects, most of which are mild and transient. With longer term use of high doses of cascara, however, adverse events have been described including several cases of clinically apparent liver injury. The time to onset of liver injury has varied from a few days to 2 months of use, and the pattern of serum enzyme elevations varied from hepatocellular to cholestatic. The liver injury ranged from mild to severe, but usually resolved rapidly with discontinuation. Immunoallergic features and autoimmune markers were not prominent or consistently present in the published cases.

### Mechanism of Injury

The liver injury due to cascara has been attributed to the direct toxicity of anthraquinone derivatives in the herbal extract; however, the clinical characteristics of the published cases suggest an idiosyncratic rather than direct hepatotoxic etiology. Other anthraquinones used to treat constipation have been implicated in causing liver injury with long term use, including sennosides and hydroxyanthraquinone. As with other herbal toxicities, the hepatic injury attributed to cascara may actually have been due to a undisclosed contaminant.

### Outcome and Management

Liver injury from long term cascara use is rare and most cases have been self-limited and rapidly reversible upon stopping the laxative. However, severe cases with acute liver failure and development of ascites and portal hypertension have been described. There is no evidence of cross sensitivity to hepatic damage with other laxatives. Restarting cascara has been associated with recurrence of liver injury and should be avoided.

Drug Class: Herbal and Dietary Supplements

Other drugs in the Anthraquinone Subclass: Senna

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Cascara – Generic

DRUG CLASS

Herbal and Dietary Supplements

SUMMARY INFORMATION

Fact Sheet at MedlinePlus, NLM (https://www.nlm.nih.gov/medlineplus/druginfo/natural/773.html)

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Cascara | 8047-27-6 | Herbal mixture | Not applicable

## ANNOTATED BIBLIOGRAPHY

References updated: 23 January 2017

Zimmerman HJ. Unconventional drugs. Miscellaneous drugs and diagnostic chemicals. In, Zimmerman, HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott,1999: pp. 731-4. (Expert review of hepatotoxicity published in 1999; cascara is not discussed).
Seeff L, Stickel F, Navarro VJ. Hepatotoxicity of herbals and dietary supplements. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 631-58. (Review of hepatotoxicity of herbal and dietary supplements [HDS]; cascara is listed as having been linked to cases of cholestatic hepatitis).
Cascara sagrada. In, PDR for Herbal Medicines. 4th ed. Montvale, New Jersey: Thomson Healthcare Inc. 2007: pp. 161-4. (Compilation of short monographs on herbal medications and dietary supplements).
Tolman KG, Hammar S, Sannella JJ. (1976). Possible hepatotoxicity of Doxidan. Ann Intern Med. (24 year old man developed fatigue 6 months after starting Doxidan [containing hydroxyanthraquinone] for chronic constipation and at 12 months developed nausea and syncope [bilirubin 0.8 mg/dL, AST 560 U/L, Alk P 339 U/L, ANA negative, slight neutropenia], liver biopsy showing chronic hepatitis, resolving within 1 month of stopping, recurring upon rechallenge).
Beuers U, Spengler U, Pape GR. (1991). Hepatitis after chronic abuse of senna. Lancet. (26 year old nurse taking high doses of senna alkaloids developed jaundice and pruritus [bilirubin not given, ALT 303 U/L, Alk P 227 U/L], resolving within a few weeks of stopping and recurring upon restarting [ALT >280 U/L]).
Franz G. (1993). The senna drug and its chemistry. Pharmacology. (Senna is dried leaflets or fruits of Cassia senna, either acutifolia [Alexandrian] or angustifolia [Indian senna], native to Northern Africa, middle East and India, similar constituents including anthraquinone glycosides, called sennosides).
Woolf GM. (1999). Senna-induced hepatotoxicity. Hepatology. (81 year old woman developed recurrent jaundice after taking senna for one month [bilirubin 3.2 rising to 29.6 mg/dL, peak ALT 1455 U/L, Alk P 168 U/L], recurring more rapidly and recovering more slowly after each of 3 episodes after reexposure).
Nadir A, Reddy D, Van Thiel DH. (2000). Cascara sagrada-induced intrahepatic cholestasis causing portal hypertension: case report and review of herbal hepatotoxicity. Am J Gastroenterol. (48 year old man developed jaundice 3 days after starting cascara sagrada [bilirubin 11.8 mg/dL, ALT 999 U/L, Alk P 309 U/L, ANA 1: 640], developing ascites, but recovering within 3 months of stopping).
Wurtz AS, Vial T, Isoard B, Saillard E. (2002). Possible hepatotoxicity from Copaltra, an herbal medicine. Ann Pharmacother. (49 year old woman developed jaundice 3 months after starting Copaltra tea [Coutarea latiflora and Centaurium erythreae] for diabetes [bilirubin 20.8 mg/dL, ALT 3010 U/L, Alk P 132 U/L], with recovery in 3 months).
De Smet PAGM. (2002). Herbal remedies. N Engl J Med. (Review of status and difficulties of herbal medications including lack of standardization, federal regulation, contamination, safety, hepatotoxicity and drug-herb interactions; specific discussion of 4 herbs with therapeutic promise: ginkgo, hawthorn, saw palmetto and St. John’s wort).
Stedman C. (2002). Herbal hepatotoxicity. Semin Liver Dis. (Review and description of patterns of liver injury, including discussion of potential risk factors, and herb-drug interactions; cascara is listed as causing liver injury).
Schiano TD. (2003). Hepatotoxicity and complementary and alternative medicines. Clin Liver Dis. (Comprehensive review of herbal associated hepatotoxicity; cascara is listed as a potential hepatotoxin).
Ernst E. (2004). Risks of herbal medicinal products. Pharmacoepidemiol Drug Saf. (Review of the adverse effects of over-the-counter herbal medications, focusing on the hepatotoxicity of kava, drug interactions with St. John’s wort, and contamination of traditional Chinese medications with heavy metals [arsenic, lead, mercury, thallium] and conventional western medications).
Russo MW, Galanko JA, Shrestha R, Fried MW, Watkins P. (2004). Liver transplantation for acute liver failure from drug-induced liver injury in the United States. Liver Transpl. (Among ~50,000 liver transplants reported to UNOS between 1990 and 2002, 270 [0.5%] were done for drug induced acute liver failure, including 7 [5%] for herbal medications, none attributed to cascara).
Seybold U, Landauer N, Hillebrand S, Goebel FD. (2004). Senna-induced hepatitis in a poor metabolizer. Ann Intern Med. (28 year old woman developed jaundice after drinking herbal tea containing senna leaves with positive rechallenge [ALT ~1390 U/L, GGT ~190 U/L], with Rhein anthrone detectable in serum).
Vanderperren B, Rizzo M, Angenot L, Haufroid V, Jadoul M, Hantson P. (2005). Acute liver failure with renal impairment related to the abuse of senna anthraquinone glycosides. Ann Pharmacother. (52 year old woman developed jaundice, acute liver failure, lactic acidosis, and phosphate wasting nephropathy after ingesting herbal tea made from senna fruits for 3 years [bilirubin 6.2 mg/dL, ALT 9160 U/L, INR 5.3], requiring ventilator support, ultimately resolving).
Sonmez A, Yilmaz MI, Mas R, Ozcan A, Celasun B, Dogru T, Taslipinar A, Kocar IH. (2005). Subacute cholestatic hepatitis likely related to the use of senna for chronic constipation. Acta Gastroenterol Belg. (77 year old male developed jaundice after taking a senna preparation for constipation for 3 months [bilirubin 4.9 rising to 16.9 mg/dL, ALT 657 U/L, Alk P 160 U/L], resolving within 1 month of stopping the herbal).
Bruguera M, Herrera S, Lazaro E, Madurga M, Navarro M, De Abajo FJ. (2007). Gastroenterol Hepatol. (Five cases of hepatotoxicity of Copalchi in 4 men and 1 woman ages 59 to 77 years, taking herb for 2 to 13 months [bilirubin 0.7-13 mg/dL, ALT 403-865 U/L, GGT 54-116 U/L], resolving in all).
García-Cortés M, Borraz Y, Lucena MI, Peláez G, Salmerón J, Diago M, Martínez-Sierra MC, et al. (2008). Liver injury induced by “natural remedies”: an analysis of cases submitted to the Spanish Liver Toxicity Registry. Rev Esp Enferm Dig. (Among 521 cases of drug induced liver injury submitted to Spanish registry, 13 [2%] were due to herbals, including one due to Rhamnus purshianus [cascara], with onset after 2 months [bilirubin 7.1 mg/dL, ALT 56 times ULN, Alk P normal], resolving in 3 months).
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J, Drug Induced Liver Injury Network (DILIN). (2008). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology. (Among 300 cases of drug induced liver disease in the US collected between 2004 and 2008, 9% of cases were attributed to herbal medications, but none were specifically linked to cascara).
Freeman HJ. (2008). "Melanosis" in the small and large intestine. World J Gastroenterol. (Pigment found in small and large intestine with long term anthracene laxative [cascara, senna, aloes and rhubarb], use is usually lipofuscin rather than hemosiderin or melanin and is present in macrophages in the lamina propria).
Jacobsen C, Semb S, Kromann-Andersen H. (2009). Ugeskr Laeger. (49 year old woman developed jaundice 4 weeks after starting daily cascara sagrada for constipation [bilirubin 8.4 rising to 24.6 mg/dL, ALT 944 U/L, ascites], resolving within 4 months of stopping).
Jacobsson I, Jönsson AK, Gerdén B, Hägg S. (2009). Spontaneously reported adverse reactions in association with complementary and alternative medicine substances in Sweden. Pharmacoepidemiol Drug Saf. (Review of 778 spontaneous reports of adverse reactions to herbals to Swedish Registry does not list or mention senna or cascara).
Mueller-Lissner SA, Wald A. Constipation in adults. Clin Evid (Online) 2010 Jul 5; 2010. pii: 0413. (Review of evidence of efficacy of conventional therapies of constipation; states that there is no published evidence from randomized controlled trials for benefit of cascara for idiopathic chronic constipation).
Vitalone A, Menniti-Ippolito F, Raschetti R, Renda F, Tartaglia L, Mazzanti G. (2012). Surveillance of suspected adverse reactions to herbal products used as laxatives. Eur J Clin Pharmacol. (Among 519 adverse events attributed to herbals reported to an Italian registry between 2002 and 2011, 26 were related to herbal laxatives, including 3 cases of liver injury, 1 due to cascara and 2 to senna).
Teschke R, Wolff A, Frenzel C, Schulze J, Eickhoff A. (2012). Herbal hepatotoxicity: a tabular compilation of reported cases. Liver Int. (A systematic compilation of all publications on the hepatotoxicity of specific herbals identified 185 publications on 60 different herbs, herbal drugs and supplements, including 1 implicating cascara [Nadir 2000] and 3 senna [Beuers 1991, Seybold 2004, Vanderperren 2005]).
Bunchorntavakul C, Reddy KR. (2013). Review article: herbal and dietary supplement hepatotoxicity. Aliment Pharmacol Ther. (Systematic review of the literature on HDS associated hepatotoxicity mentions that cascara has been implicated in causing clinically apparent acute liver injury).
Teschke R, Schulze J, Schwarzenboeck A, Eickhoff A, Frenzel C. (2013). Herbal hepatotoxicity: suspected cases assessed for alternative causes. Eur J Gastroenterol Hepatol. (Review of the literature of case series of suspected HDS related liver injury found evidence of other explanations for the liver injury in 19 of 23 publications involving 278 of 573 patients [49%], and that these other diagnoses weakened the causality assessment in most instances; cascara associated cases not mentioned).
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. (2013). Incidence, presentation and outcomes in patients with drug-induced liver injury in the general population of Iceland. Gastroenterology. (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period, including 15 [16%] due to herbal and dietary supplements, but none were attributed to cascara containing products).
Licata A, Macaluso FS, Craxì A. (2013). Herbal hepatotoxicity: a hidden epidemic. Intern Emerg Med. (Review and commentary on herb rekated hepatotoxicity discusses pyrrolizidine alkaloids, green tea, Echinacea, kava, usnic acid, ephedra and products made by Herbalife, Hydroxycut and LipoKinetix; no mention of cascara containing products).
Navarro VJ, Seeff LB. (2013). Liver injury induced by herbal complementary and alternative medicine. Clin Liver Dis. (Review of HDS induced liver injury including regulatory problems, difficulties in diagnosis and causality assessment; no mention of cascara contianing products).
Navarro VJ, Barnhart H, Bonkovsky HL, Davern T, Fontana RJ, Grant L, Reddy KR, et al. (2014). Liver injury from herbals and dietary supplements in the U.S. Drug-Induced Liver Injury Network. Hepatology. (Among 85 cases of HDS associated liver injury [not due to anabolic steroids] enrolled in a US prospective study between 2004 and 2013, none were attributed specifically to cascara).
Navarro VJ, Lucena MI. (2014). Hepatotoxicity induced by herbal and dietary supplements. Semin Liver Dis. (Review of HDS induced liver injury including regulatory problems, difficulties in diagnosis and causality assessment; lists cascara as possibly causing cholestatic hepatitis).
Seeff LB, Bonkovsky HL, Navarro VJ, Wang G. (2015). Herbal products and the liver: a review of adverse effects and mechanisms. Gastroenterology. (Extensive review of possible beneficial as well as harmful effects of herbal products on the liver mentions that multi-ingredient supplements have been implicated in many cases of liver injury; cascara is not discussed).
Nakasone ES, Tokeshi J. (2015). A serendipitous find: A case of cholangiocarcinoma identified incidentally after acute liver injury due to cascara sagrada ingestion. Hawaii J Med Public Health. (77 year old woman developed jaundice shortly after a 3 day course of an over-the-counter cascara product [bilirubin 18.5 mg/dL, ALT 465 U/L, Alk P not given], while imaging showed cholangiocarcinoma; no follow up or justification of diagnosis of cascara induced liver injury given).
Stickel F, Shouval D. (2015). Hepatotoxicity of herbal and dietary supplements: an update. Arch Toxicol. (Extensive review of liver injury due to HDS lists cascara as possibly causing cholestatic hepatitis).
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al., United States Drug Induced Liver Injury Network. (2015). Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology. (Among 899 cases of drug induced liver injury enrolled in a prospective database between 2004 and 2012, HDS were implicated in 145 [16%], but none specifically implicated cascara: see Navarro [2014]).

## OTHER REFERENCE LINKS

1 Recent References on Cascara: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=cascara+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Cascara: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=cascara)